# Serotonin Receptor Agonists (Triptans)

## OVERVIEW

### Introduction

The triptans are a group of serotonin receptor agonists that are useful in the therapy of vascular headaches and migraine. The triptans are generally used in low doses for a limited period of time and have not been associated with serum enzyme elevations, but some have been implicated in rare instances of clinically apparent, acute cholestatic hepatitis.

### Background

The triptans (trip' tans) are synthetic serotonin receptor agonists that are used in the therapy of migraine and vascular headache. Serotonin (5-hydroxytryptamine or 5-HT) is a monoamine that has multiple actions, acting as a neurotransmitter and bioactive amine. The diversity of actions of serotonin is partially due to the multitude of different serotonin receptors and their tissue location. There are at least 15 classes of serotonin receptors which have overlapping actions, but variable distribution and intracellular pathways of response to stimulation and inhibition. The triptans are serotonin agonists with high affinity for the 5-HT1B and 5-HT1D receptors which are found on smooth-muscle cells of blood vessels. Simulation of the 5-HT1D receptor results in constriction of intracranial blood vessels. The triptans may also block the release of vasoactive peptides from perivascular trigeminal neurons through their action at presynaptic 5-HT1D receptors on nerve terminals. Regardless, the triptans have been found to be effective in preventing or aborting migraine headaches with shortening of the period of pain and symptoms. The triptans are considered “first line” agents for patients whose vascular headaches do not reliably respond to conventional analgesics. They generally have a more rapid onset of action and fewer side effects than the ergot alkaloids. Seven triptans are approved for use in the United States including almotriptan (al" moe trip' tan), eletriptan (el" e), forvatriptan (froe" va), naratriptan (nar"' a), rizatriptan (rye" za, sumatriptan (soo" ma) and zolmitriptan (zole" ma). Generic formulations are available for most agents. The short acting triptans include sumatriptan, almotriptan, eletriptan, rizatriptan and rolmitriptan and generally provide relief within 30 to 60 minutes. The longer activing oral triptans include naratriptan and frovatriptan which have a slower onset of action but may be better tolerated. Intranasal formulations may have a more rapid onset of action as do subcutaneous administered forms. Brand names, year approved, tablet or wafer size, usual dose and maximum daily recommended doses are shown in the Table.

Generic (Brand) Name | Year Approved | Tablet (or Wafer) Size | Usual Initial Dose | Maximum 24 Hour Dose
Almotriptan (Axert) | 2001 | 6.25 and 12.5 mg | 12.5 mg | 25 mg
Eletriptan (Relpax) | 2002 | 20 and 40 mg | 40 mg | 80 mg
Frovatriptan (Frova) | 2001 | 2.5 mg | 2.5 mg | 7.5 mg
Naratriptan (Amerge) | 1998 | 1 and 2.5 mg | 2.5 mg | 5 mg
Rizatriptan (Maxalt) | 1998 | 5 and 10 mg | 10 mg | 30 mg
Sumatriptan (Imitrex) | 1997 | 25, 50 and 100 mg* | 50 mg | 200 mg
Zolmitriptan (Zomig) | 1997 | 2.5 mg and 5 mg** | 5 mg | 10 mg

* Also available as nasal spray, transdermal patch and solution for injection.

** Also available in orally disintegrating tablets and as nasal spray.

Early therapy is recommended in patients with recurrent migraine, and typically the dose is repeated in 2 to 4 hours if relief has not occurred. However, the total dosage should be limited to 2 to 3 doses per 24 hour period. Parenteral and intranasal administration is helpful in patients with nausea and vomiting. Chronic, long term use of triptans to prevent migraines has been studied, but is not currently approved. The seven triptans have similar side effect profiles which include “triptan sensations” characterized by tightening of the throat, chest, neck and limbs with paresthesias and hot or cold sensations. Triptans may also cause flushing, headache, somnolence and fatigue. Rare but potentially severe adverse events include medication overuse syndrome, cerebrovascular and cardiovascular events such as myocardial infarction and stroke, serotonin syndrome and anaphylaxis.

### Hepatotoxicity

In large prospective controlled trials, the different triptans have not been associated with serum enzyme elevations or hepatotoxicity; however, the frequency of monitoring in most studies was limited and rates of ALT elevations not reported. There have been rare individual reports of cholestatic hepatitis after the use of triptans, largely associated with zolmitriptan. Typically, the onset of injury was within 1 to 2 weeks of taking several doses of the zolmitriptan for a protracted and severe migraine attack. Recurrent jaundice with intermittent therapy has also been reported (Case 1). The pattern of serum enzyme elevations was mixed or cholestatic, and recovery was complete within 1 to 2 months. Allergic manifestations (rash, fever, eosinophilia) were not present and autoantibodies did not develop.

Likelihood score, zolmitriptan: D (probable rare cause of clinically apparent liver injury).

Likelihood score, rizatriptan: E* (suspected but unproven cause of liver injury).

Likelihood score, other triptans: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of idiosyncratic liver injury after triptan use is not known, but is likely due to a toxic metabolite causing an acute, cholestatic hepatitis-like injury. An intriguing hypothesis is that the serotonin agonist activity causes biliary dyskinesis and functional obstruction.

### Outcome and Management

Reported cases of hepatotoxicity from the triptans have been mild-to-moderate in severity, accompanied by symptoms and jaundice, but without acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There have been too few cases reported to know whether there is cross sensitivity to hepatotoxicity among the various triptans. Rechallenge should be avoided and switching to another triptan should be done with caution.

Agents used specifically in management of migraines and vascular headaches include: the ergot alkaloids, ergotamine and dihydroergotamine; and, the serotonin receptor agonists (triptans), including almotriptan, eletriptan, frovatriptan, naratriptan, rizatriptan, sumatriptan and zolmitriptan.

Drug Class: Migraine Headache Agents, Vasoconstrictor Agents

## CASE REPORT

### Case 1. Recurrent jaundice in a patient taking zolmitriptan for migraine headaches.

[Modified from: Deixler E, Helmke K. [Extrahepatic cholestasis during therapy with zolmitriptan (AscoTop)]. Z Gastroenterol 2005; 43: 1045-9. German. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16142613)]

A 62 year old man developed recurrent episodes of jaundice and abdominal pain approximately 6 months after starting zolmitriptan (5 mg, averaging 3-4 times weekly) for migraine headaches. During an early attack, serum bilirubin was 6.6 mg/dL (4.5 mg/dL direct), ALT 230 U/L, Alk P 350 U/L, GGT 375 U/L (Table). Tests for hepatitis A, B and C were negative as were routine autoantibodies. Because of recurrent bouts of jaundice were suggestive of cholangitis, he underwent cholecystectomy. Histologically, the gallbladder showed evidence of chronic inflammation, but was without stones and the extrahepatic biliary tree appeared normal. Three months after cholecystectomy, jaundice recurred. Endoscopic retrograde cholangiopancreatography again failed to show evidence of extrahepatic obstruction, but suggested dysfunction of the ampula of Vater. At that point, total serum bilirubin was 7.8 mg/dL, ALT 680 U/L, and alkaline phosphatase 205 U/L. Because zolmitriptan is a serotonin agonist and might affect gastrointestinal and biliary smooth muscle function, it was discontinued, whereupon liver test abnormalities rapidly improved. During a year of follow up, he had no further attacks of jaundice or abdominal pain and liver tests were repeatedly normal. His migraine headaches were managed with beta-blockers.

#### Key Points

Medication: | Zolmitriptan (5 mg 3-4 times weekly)
Pattern: | Mixed (R=2.7)
Severity: | 3+ (jaundice, hospitalization)
Latency: | Six months
Recovery: | One month
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
| | Zolmitriptan started for migraine headaches
6 months | 0 | 40 | 210 | 1.6 | Abdominal pain
7 months | 0 | 30 | 200 | 1.2
8 months | 0 | 110 | 360 | 6.6 | Cholecystectomy
9 months | 0 | 90 | 200 | 1.2
12 months | 0 | 690 | 218 | 7.8 | ERCP
| | Zolmitriptan stopped
13 months | 1 month | 50 | 105 | 1.1
14 months | 2 months | 25 | 90 | 1.0
18 months | 6 months | 25 | 70 | 1.0
Normal Values | | <35 | <130 | <1.2

* Selected values estimated from Figure 1.

#### Comment

This patient had intermittent and fluctuating jaundice that suggested intermittent extrahepatic obstruction due to choledocholithiasis. The possibility that zolmitriptan was the cause arose only after repeated evaluations failed to show frank extrahepatic obstruction, but indicated biliary akinesia or abnormalities in the function of the ampula of Vater. The intermittency and variable doses of the migraine medication made it difficult to incriminate its use and perhaps explained the fluctuating course of liver injury. The possibility that the triptans may affect biliary kinesis is intriguing (but unproven) explanation for occasional instances of cholestatic jaundice.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Almotriptan – Generic, Almogran®, Axert®

Eletriptan – Relpax®

Frovatriptan – Frova®

Naratriptan – Generic, Amerge®

Rizatriptan – Maxalt®

Sumatriptan – Generic, Imitrex®

Zolmitriptan – Zomig®

DRUG CLASS

Migraine Headache Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=triptans)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Almotriptan | 154323-57-6 | C17-H25-N3-O2-S | Almotriptan Chemical Structure
Eletriptan | 177834-92-3 | C22-H26-N2-O2-S.Br-H | Eletriptan Chemical Structure
Frovatriptan | 158930-17-7 | C14-H17-N3-O.C4-H6-O4.H2-O | Frovatriptan Chemical Structure
Naratriptan | 121679-13-8 | C17-H25-N3-O2-S | Naratriptan Chemical Structure
Rizatriptan | 144034-80-0 | C15-H19-N5 | Rizatriptan Chemical Structure
Sumatriptan | 103628-46-2 | C14-H21-N3-O2-S | Sumatriptan Chemical Structure
Zolmitriptan | 139264-17-8 | C16-H21-N3-O2 | Zolmitriptan Chemical Structure

## REFERENCES

References updated: 10 February 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; ergotamine and triptans are not discussed).
Larrey D, Ripault MP. Benzodiazepines. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 455. (Review of hepatotoxicity of neuroleptic drugs does not mention ergotamine or the triptans).
Sanders-Bush E, Mayer SE. 5-Hydroxytryptamine (Serotonin): receptor agonists and antagonists. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 297-315. (Textbook of pharmacology and therapeutics).
Block GA, Goldstein J, Polis A, Reines SA, Smith ME. Efficacy and safety of rizatriptan versus standard care during long-term treatment for migraine. Rizatriptan Multicenter Study Groups. Headache 1998; 38: 764-71. (Among 1831 patients treated for up to 12 months and experiencing 46,773 migraine attacks, pain relief was achieved in 2 hours in 80-90% on rizatriptan and 70% on standard care; side effects were similar and there were “no meaningful differences in the incidences of drug related laboratory adverse events”). 11284464
O'Quinn S, Davis RL, Gutterman DL, Pait GD, Fox AW. Prospective large-scale study of the tolerability of subcutaneous sumatriptan injection for acute treatment of migraine. Cephalalgia 1999; 19: 223-31. (Among 12,339 patients in an open-label study of sumatriptan injections for migraine attacks, 4.1% had a serious adverse event, but only 20 [0.2%] were considered related to sumatriptan and none were hepatic). 10376167
Heywood J, Bomhof MA, Pradalier A, Thaventhiran L, Winter P, Hassani H. Tolerability and efficacy of naratriptan tablets in the acute treatment of migraine attacks for 1 year. Naratriptan Long-Term Study Group. Cephalalgia 2000; 20: 470-4. (Among 417 patients with 15,301 migraine attacks in an open-label study of naratriptan, the most common side effects were nausea, salivation and drowsiness [2-3%] and no mention of hepatitis or liver related adverse events). 11037743
Geraud G, Compagnon A, Rossi A; COZAM Study Group. Zolmitriptan versus a combination of acetylsalicylic acid and metoclopramide in the acute oral treatment of migraine: a double-blind, randomised, three-attack study. Eur Neurol 2002; 47: 88-98. (Among 666 patients with migraine treated with either zolmitriptan or aspirin/metoclopramide, side effects of paresthesias and dizziness were more common with zolmitriptan; no mention of any hepatic side effects). 11844897
Diener HC, Jansen JP, Reches A, Pascual J, Pitei D, Steiner TJ; Eletriptan and Cafergot Comparative Study Group. Efficacy, tolerability and safety of oral eletriptan and ergotamine plus caffeine (Cafergot) in the acute treatment of migraine: a multicentre, randomised, double-blind, placebo-controlled comparison. Eur Neurol 2002; 47: 99-107. (Among 733 patients with migraine treated with either eletriptan or ergotamine/caffeine, side effects were transient and predominately mild or moderate; “No clinically significant laboratory…abnormalities were recorded”). 11844898
Snow V, Weiss K, Wall EM, Mottur-Pilson C; American Academy of Family Physicians; American College of Physicians-American Society of Internal Medicine. Pharmacologic management of acute attacks of migraine and prevention of migraine headache. Ann Intern Med 2002; 137: 840-9. (Guidelines for management of acute migraine and chronic prevention; recommends use of nasal dihydroergotamine or a triptan in patients whose migraines fail to respond to aspirin, acetaminophen or nonsteroidal antiinflammatory agents). 12435222
Jamieson DG. The safety of triptans in the treatment of patients with migraine. Am J Med 2002; 112: 135-40. (Review of the safety of triptans in migraine therapy focusing on vascular risk, stroke, myocardial infarction and ischemic bowel disease; no mention of hepatotoxicity). 11835952
Redondo Cerezo E, Espinosa Aguilar MD, Nogueras López F, Martín-Vivaldi Martínez R. [Zolmitriptan-induced hepatotoxicity]. Gastroenterol Hepatol 2003; 26: 664. Spanish. (48 year old woman developed jaundice and itching one week after taking three doses of zolmitriptan for a severe bout of migraine [bilirubin 4.3 mg/dL, ALT 331 U/L, Alk P 530 U/L], resolving spontaneously and no rechallenge). 14670242
Ashcroft DM, Millson D. Naratriptan for the treatment of acute migraine: meta-analysis of randomised controlled trials. Pharmacoepidemiol Drug Saf 2004; 13: 73-82. (Metaanalysis of 10 trials of naratriptan for acute migraine with 4499 participants found lower rates of adverse effects with naratriptan compared to other triptans, but specifics of side effects were not provided; no mention of ALT elevations or liver injury). 14998068
Deixler E, Helmke K. [Extrahepatic cholestasia during therapy with Zolmitriptan (AscoTop)]. Z Gastroenterol 2005; 43: 1045-9. German. (62 year old man developed recurrent, fluctuating jaundice and abdominal pain 6 months after starting zolmitriptan [3-4 times weekly] for migraine [bilirubin 7.8 mg/dL, ALT 690 U/L, Alk P 218 U/L], which recurred after cholecystectomy, but resolved within a month of stopping zolmitriptan: Case 1). 16142613
Loj J, Solomon GD. Migraine prophylaxis: who, why, and how. Cleve Clin J Med 2006; 73: 793-4, 797, 800-1 passim. (Preventive therapy of migraine has limited efficacy and may take 2-3 months to have an effect; the most commonly used agents are beta-blockers, calcium channel blockers, anticonvulsants, tricyclic antidepressants and selective serotonin reuptake inhibitors [SSRIs]). 16970133
Chen LC, Ashcroft DM. Meta-analysis examining the efficacy and safety of almotriptan in the acute treatment of migraine. Headache 2007; 47: 1169-77. (Metaanalysis of 8 controled trials of almotriptan for acute migraine with 4995 participants; no mention of ALT elevations or hepatotoxicity). 17883521
Chen LC, Ashcroft DM. Meta-analysis of the efficacy and safety of zolmitriptan in the acute treatment of migraine. Headache 2008; 48: 236-47. (Metaanalysis of 24 controled trials of zolmitriptan for acute migraine with 15,408 participants; no mention of ALT elevations or hepatotoxicity). 18179569
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to agents used to treat migraine headaches). 18955056
Whyte CA, Tepper SJ. Adverse effects of medications commonly used in the treatment of migraine. Expert Rev Neurother 2009; 9: 1379-91. (Extensive review of common side effects of medications used to treat migraine; 1-8% of patients who take triptans develop “triptan sensations with throat and chest tightness, numbness and tingling and hot/cold sensations which may vary with different forms”). 19769452
Loder E. Triptan therapy in migraine. N Engl J Med 2010; 363: 63-70. (Review of the pathophysiology of migraine headache and the mechanism of action, efficacy, tolerance and safety of the serotonin receptor agonists [triptans]; no mention of ALT elevations of clinically apparent liver injury). 20592298
Taylor FR. Acute treatment of migraine headaches. Semin Neurol 2010; 30: 145-53. (Review of diagnosis and acute management of migraine headaches). 20352584
Berenson F, Vasconcellos E, Pakalnis A, Mao L, Biondi DM, Armstrong RB. Long-term, open-label safety study of oral almotriptan 12.5 mg for the acute treatment of migraine in adolescents. Headache 2010; 50: 795-807. (Among 319 adolescents with migraine headache treated with almotriptan for 12 months, "minor changes (increases and decreases) in mean values for hematology, serum, chemistry and urinalysis parameters were observed, but there were no consistent trends"). 20546320
Drugs for migraine. Treat Guidel Med Lett 2011; 9: 7-12. (Concise review of current medications used for migraine; no discussion of hepatotoxicity). 21304447
Fernandez-Atutxa A, Vergara M, Gil M, Dalmau B, Miquel M, Sanchez-Delgado J, Casas M. [Rizatriptan-induced liver toxicity. Report of a case]. Gastroenterol Hepatol 2013; 36: 261-3. Spanish. (17 year old girl with migraines developed jaundice [bilirubin 7.1 mg/dL, ALT 9729 U/L, Alk P normal] two weeks after taking a 10 mg tablet of rizatriptan). 23084593
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to drugs for migraine headaches). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to the triptans or other drugs for migraine headaches). 25754159
Drugs for migraine. Med Lett Drugs Ther 2017; 59 (1514): 27-32. Corrected and republished in: JAMA 2017; 317 (21): 2230-1. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/28586886) (Concise review of current medications used for migraine; no discussion of hepatotoxicity). 28170366

## OTHER REFERENCE LINKS

1. Recent References on Triptans: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(triptans/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Triptans: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=triptans)